# Lomustine

## OVERVIEW

### Introduction

Lomustine is an orally administered alkylating agent used alone and in combination with other antineoplastic agents in the treatment of several malignancies including Hodgkin disease, lymphoma, and brain cancer. Lomustine therapy is associated with minor transient serum enzyme elevations and has been linked to rare cases of clinically apparent acute liver injury.

### Background

Lomustine (loe mus' teen: also known as CCNU) is a nitrosourea similar to carmustine (BCNU), which acts as an alkylating agent and is used in the therapy of several forms of lymphoma and solid organ cancer. Like cyclophosphamide, lomustine requires activation in the liver to form its active intermediaries which act by modifying and cross linking purine bases in DNA, thus inhibiting DNA, RNA and protein synthesis and leading to programmed cell death (apoptosis) in rapidly dividing cells. Lomustine also forms adducts with cellular proteins. Lomustine was approved for use in the United States in 1977, and its current indications include treatment of brain cancer, and Hodgkin and non-Hodgkin lymphomas. Lomustine is available as capsules of 10, 40 and 100 mg in generic forms and under the trade name CeeNU. Recommended doses vary by age, body weight and malignant condition. Lomustine is usually given in combination with other antineoplastic agents in a single oral dose of 100-130 mg/m^2^ in cycles every 6 to 8 weeks. The toxicity of lomustine is similar to other alkylating agents. Common side effects include alopecia, nausea, vomiting, diarrhea, gastrointestinal upset, nephrotoxicity, oral ulcers and bone marrow suppression.

### Hepatotoxicity

Mild and transient elevations in serum aminotransferase or alkaline phosphatase levels are found in a high proportion of patients treated antineoplastic regimens that include lomustine. The abnormalities are generally transient, do not cause symptoms and do not require dose modification. Clinically apparent liver injury from lomustine has been described, but is uncommon. The pattern of serum enzyme elevations were described as cholestatic and onset was after 3 to 4 months of therapy, but otherwise its clinical characteristics have not been clearly characterized. Lomustine is often given in combination with other antineoplastic agents, many of which are also hepatotoxic, so the effect of lomustine in causing liver injury is often difficult to assess. Lomustine has not been associated specifically with sinusoidal obstruction syndrome, but it is not generally given in high doses or used for myeloablation in preparation for bone marrow transplantation, the situations in which this syndrome generally occurs.

Likelihood score: D (possible cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of idiosyncratic hepatotoxicity from lomustine is not known. Lomustine is extensively metabolized by hepatic cytochrome P450 system.

### Outcome and Management

The severity of liver injury ranges from mild elevations in liver enzymes to mild and self limited cholestatic liver injury. It is not known whether patients with acute liver injury due to lomustine have cross sensitivity to hepatic injury with other alkylating agents.

Drug Class: Antineoplastic Agents, Alkylating Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lomustine – CeeNU®

DRUG CLASS

Antineoplastic Agents, Alkylating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lomustine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Lomustine | 13010-47-4 | C9-H16-Cl-N3-O2 | Lomustine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 03 June 2019

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; mentions that lomustine has been linked to serum aminotransferase elevations).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 541-67. (Review of hepatotoxicity of cancer chemotherapeutic agents; lomustine is listed as an uncommon cause of liver injury but capable of causing sinusoidal obstruction syndrome at high doses).
Wellstein A, Giaconne G, Atkins MB, Sausville EA. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 20181, pp. 1167-1201. (Textbook of pharmacology and therapeutics).
De Vita VT, Carbone PP, Owens AH Jr, Gold GL, Krant MJ, Edmonson J. Clinical trials with 1,3-bis (2-chloroethyl)-1-nitrosourea, NSC-409962. Cancer Res 1965; 25: 1876-81. (Preliminary studies of BCNU in 144 patients with malignancies, including different dose schedules; AST elevations occurred in 15% after 13-63 days and were self-limited in all; liver toxicity may have contributed to the death of one patient). 5858571
Hansen HH, Selawry OS, Muggia FM, Walker MD. Clinical studies with 1-(2-chloroethyl)-3-cyclohexyl-1-nitrosourea (NSC 79037). Cancer Res 1971; 31: 223-7. (Preliminary studies of CCNU in 40 patients with malignancies; there was no consistent hepatic dysfunction; AST elevations occurred in one patient). 4926242
Lokich JJ, Drum DE, Kaplan W. Hepatic toxicity of nitrosourea analogues. Clin Pharmacol Ther 1974; 16: 363-7. (2 cases: 70 year old man with metastatic colon cancer and cirrhosis developed jaundice 6 weeks after a 5 day course of carmustine and streptozotocin [bilirubin 6.2 mg/dL, but no other information given]; 66 year old man with pancreatic cancer developed jaundice 2 weeks after carmustine and streptozotocin [bilirubin 3.5 mg/dL, AST 30 U/L, Alk P 135 U/L], with recovery after stopping). 4852251
Lessner HE, Vogler WR. Toxicity study of BCNU (NSC-409965) given orally. Cancer Chemother Rep 1974; 58: 407-11. (Pilot study of carmustine alone in various oral doses in 104 patients with cancer; two patients developed liver toxicity, one with jaundice and elevated Alk P, but relationship to drug was uncertain). 4601671
de Labarthe B, Chahinian P, Gosselin M, Goasguen J, Ferrand B, Danrigal A, Israel L. [Hepatic damage during treatment with C.C.N.U]. Sem Hop Ther 1975; 51: 309-14. French. (50 year old woman with metastatic breast cancer developed jaundice during the fourth month of lomustine monotherapy [every 3 weeks], with bilirubin rising to 10.1 mg/dL, ALT 2900 U/L and Alk P 3-4 times ULN, ultimately recovered but died of metastatic disease several months later). 1224203
Jones RJ, Lee KS, Beschorner WE, Vogel VG, Grochow LB, Braine HG, Vogelsang GB, et al. Veno-occlusive disease of the liver following bone marrow transplantation. Transplantation 1987; 4: 778-83. (Among 235 patients undergoing bone marrow transplantation between 1982 and 1985, sinusoidal obstruction syndrome [SOS] developed in 52 [22%] of whom half died, making SOS the third most common cause of death in this population). 3321587
Kim L, Hochberg FH, Thornton AF, Harsh GR 4th, Patel H, Finkelstein D, Louis DN. Procarbazine, lomustine, and vincristine (PCV) chemotherapy for grade III and grade IV oligoastrocytomas. J Neurosurg 1996; 85: 602-7. (Among 32 pateitns with astrocytotoma treated with a total of 124 cycles of procarbazine, lomustine and vincristine, there "were no reports of hepatic toxicity" and most dose adjustments were for hematologic toxicities). 8814163
McDonald GB. Hepatobiliary complications of hematopoietic cell transplantation, 40 years on. Hepatology 2010; 51: 1450-60. (Review of liver complications of bone marrow [hematopoietic cell] transplantation, which have become less frequent with better understanding of their causes and means of prevention; the rate of sinusoidal obstruction syndrome has decreased because of avoidance of more aggressive ablative therapies [total body irradiation and high doses of cyclophosphamide] and better understanding of pharmacokinetics of the alkylating agents; lomustine is not specifically discussed). 20373370
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 40 of which were attributed to antineoplastic agents, but none specifically to lomustine). 24552865
Douros A, Bronder E, Andersohn F, Klimpel A, Thomae M, Sarganas G, Kreutz R, et al. Drug-induced liver injury: results from the hospital-based Berlin Case-Control Surveillance Study. Br J Clin Pharmacol 2015; 79: 988-99. (Among 198 patients with hepatitis of uniknown cause enrolled in a prospective database from 51 Berlin hospitals between 2002 and 2011, none were attributed to lomustine). 25444550
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 cases were attributed to antineoplastic agents, but none to lomustine). 25754159
Jutras G, Bélanger K, Letarte N, Adam JP, Roberge D, Lemieux B, Lemieux-Blanchard É, et al. Procarbazine, lomustine and vincristine toxicity in low-grade gliomas. Curr Oncol 2018; 25: e33-e39. (Among 57 patients treated with a regimen of procarbazine, lomustine and vincristine for low grade gliomas between 2005 and 2016, hematologic, hepatic and renal toxicities were common, ALT elevations arising in 65% of patients which were above 5 times ULN in 18%, but the major dose limiting toxicities were hematologic). 29507493

## OTHER REFERENCE LINKS

1. Recent References on Lomustine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Lomustine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Lomustine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lomustine)